# Sorafenib

## OVERVIEW

### Introduction

Sorafenib is an oral multi-kinase inhibitor that is used in the therapy of advanced renal cell, liver and thyroid cancer. Sorafenib has been associated with a low rate of transient elevations in serum aminotransferase levels during therapy that are generally mild and asymptomatic. Sorafenib has also been linked to rare instances of clinically apparent liver injury which can be severe and even fatal.

### Background

Sorafenib (soe raf’ e nib) is an orally available, small molecule, multi-specific tyrosine kinase inhibitor with activity against vascular endothelial growth factors (VEGF) receptors -1, -2 and -3 as well as against the receptor for platelet derived growth factor (PDGF) and several Raf kinases. Inhibition of these kinases decreases angiogenesis, which plays an important role in the growth and spread of several forms of solid tumors. Sorafenib received approval for use in the United States in 2005 for therapy of advanced renal cell carcinoma, and indications were subsequently expanded to hepatocellular carcinoma in 2007 and refractory thyroid cancer in 2014. Sorafenib is available in tablets of 200 mg under the brand name Nexavar. The typical dose is 400 mg twice daily, continued until there is tumor progression or unacceptable toxicity. Side effects are common and can include fatigue, diarrhea, anorexia, weight loss, nausea, abdominal pain, hand-foot syndrome, rash, hair loss, pruritus, bleeding and sensory neuropathy. Uncommon, but potentially severe side effects include bone marrow suppression, bleeding, venous thrombosis, gastrointestinal perforation, QTc prolongation and Stevens Johnson syndrome.

### Hepatotoxicity

In large clinical trials of sorafenib, elevations in serum aminotransferase levels were common, occurring in up to half of patients, but values greater than 5 times the upper limit of normal (ULN) occurred in only 1% to 3% of treated subjects. In addition, there have been several single case reports of clinically apparent liver injury arising during sorafenib therapy which was often severe and occasionally fatal. The onset of acute liver injury ranged from a few days to 8 weeks of starting sorafenib, and the pattern of injury was typically hepatocellular with marked elevations in serum aminotransferase levels. Immunoallergic and autoimmune features were absent. Recovery was usually rapid once sorafenib was stopped, but some cases were associated with progressive liver injury and hepatic failure. Most of the reports of severe liver injury occurred in patients being treated for hepatocellular carcinoma who also had cirrhosis or in patients receiving other potentially hepatotoxic drugs31.

Likelihood score: B (likely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of injury accounting for serum enzyme elevations during sorafenib therapy is not known. Sorafenib is metabolized in the liver largely through the CYP 3A4 pathway and liver injury may be related to production of a toxic intermediate. Sorafenib is susceptible to drug-drug interactions with agents that inhibit or induce hepatic CYP 3A4 activity. Sorafenib, like many tyrosine kinase inhibitors can inhibit UDP glucuronosyltransferase activity which can result in mild indirect hyperbilirubinemia and may predispose to acetaminophen toxicity.

### Outcome and Management

Monitoring of routine liver tests is recommended during sorafenib therapy. Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) or any elevations accompanied by jaundice or symptoms should lead to dose reduction or temporary cessation. Sorafenib has been implicated in cases of acute liver failure, but not in instances of chronic hepatitis or vanishing bile duct syndrome. There does not appear to be cross reactivity in risk for hepatic injury between sorafenib and other kinase inhibitors including the angiogenesis inhibitors such axitinib and sunitinib.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Sorafenib – Nexavar®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Sorafenib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Sorafenib | 284461-73-0 | C21-H16-Cl-F3-N4-O3 | Sorafenib chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 22 June 2018

Abbreviations: HCC, hepatocellular carcinoma; NSCLC, non-small cell lung cancer.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors such as sorafenib).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 541-67. (Review of hepatotoxicity of cancer chemotherapeutic agents; imatinib, gefitinib, erlotinib and crizotinib are discussed, but not sorafenib).
Chabner BA, Barnes J, Neal J, Olson E, Mujagic H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-54. (Textbook of pharmacology and therapeutics).
Elser C, Siu LL, Winquist E, Agulnik M, Pond GR, Chin SF, Francis P, et al. Phase II trial of sorafenib in patients with recurrent or metastatic squamous cell carcinoma of the head and neck or nasopharyngeal carcinoma. J Clin Oncol 2007; 25: 3766-73. (Among 27 patients with refractory head and neck cancers treated with sorafenib, the median survival was 4.2 months; side effects included fatigue, stomatitis, hypertension, hand foot syndrome and neuropathy, with mild AST elevations in 26% of patients and no clinically apparent liver injury). 17704426
Schramm C, Schuch G, Lohse AW. Sorafenib-induced liver failure. Am J Gastroenterol 2008; 103: 2162-3. (65 year old woman with hepatocellular cancer [HCC] and cirrhosis due to nonalcoholic steatohepatitis developed jaundice 6 weeks after starting sorafenib [bilirubin 22 mg/dL, AST 1724 U/L, INR 2.9], with progressive liver failure, but prompt resolution after initiation of prednisolone). 18796127
Cheng AL, Kang YK, Chen Z, Tsao CJ, Qin S, Kim JS, Luo R, et al. Efficacy and safety of sorafenib in patients in the Asia-Pacific region with advanced hepatocellular carcinoma: a phase III randomised, double-blind, placebo-controlled trial. Lancet Oncol 2009; 10: 25-34. (Among 271 Asian patients with HCC, median survival was 6.5 months in those treated with sorafenib vs 4.2 with placebo, and adverse events included hand-foot syndrome [45%], diarrhea [25%], fatigue [20%], rash [20%] and hypertension [19%], with no increase in "liver dysfunction" with sorafenib and no treatment related deaths). 19095497
Llovet JM, Ricci S, Mazzaferro V, Hilgard P, Gane E, Blanc JF, de Oliveira AC, et al.; SHARP Investigators Study Group. Sorafenib in advanced hepatocellular carcinoma. N Engl J Med 2008; 359: 378-90. (In a study of 602 patients with advanced HCC, sorafenib treatment [in comparison to placebo] increased median survival from 7.9 to 10.7 months, but was also associated with higher rate of adverse events including fatigue, anorexia, diarrhea, weight loss, alopecia, and hand-foot syndrome, but not "liver dysfunction" [<1% vs 0%]). 18650514
Gupta-Abramson V, Troxel AB, Nellore A, Puttaswamy K, Redlinger M, Ransone K, Mandel SJ, et al. Phase II trial of sorafenib in advanced thyroid cancer. J Clin Oncol 2008; 26: 4714-9. (Among 30 patients with advanced thyroid cancer treated with sorafenib, elevated liver tests occurred in 4 patients, one of whom developed marked elevations starting at 8 weeks and died of liver failure 3 months later). 18541894
Di Lorenzo G, Cartenì, Autorino R, Bruni G, Tudini M, Rizzo M, Aieta M, et al. Phase II study of sorafenib in patients with sunitinib-refractory metastatic renal cell cancer. J Clin Oncol 2009; 27: 4469-74. (Among 52 patients with refractory renal cell cancer treated with sorafenib for 1-10 months, clinical responses were infrequent, but side effects were common including fatigue, diarrhea, neutropenia, nausea, anemia, rash and thrombocytopenia; ALT elevations occurred in 6%, but all were ≤5 times ULN). 19652053
Escudier B, Eisen T, Stadler WM, Szczylik C, Oudard S, Staehler M, Negrier S, et al. Sorafenib for treatment of renal cell carcinoma: Final efficacy and safety results of the phase III treatment approaches in renal cancer global evaluation trial. J Clin Oncol 2009; 27: 3312-8. (Among 903 patients with advanced renal cell cancer treated with sorafenib or placebo, the median overall survival was similar in both groups [17.8 vs 15.2 months], but side effects more common with sorafenib were diarrhea [48% vs 11%], rash [41% vs 13%], hand-foot syndrome [33% vs 8%], fatigue [29% vs 16%], nausea [19% vs 12%]; ALT elevations and hepatotoxicity were not mentioned). 19451442
Llanos L, Bellot P, Zapater P, Perez-Mateo M, Such J. Acute hepatitis in a patient with cirrhosis and hepatocellular carcinoma treated with sorafenib. Am J Gastroenterol 2009; 104: 257-8. (73 year old man with recurrence of HCC after liver transplantation developed jaundice 4 days after starting sorafenib [bilirubin 2.8 rising to ~12 mg/dL, ALT 109 U/L, Alk P not given, INR 1.48], resolving within 6 weeks of onset). 19098892
Wörns MA, Weinmann A, Pfingst K, Schulte-Sasse C, Messow CM, Schulze-Bergkamen H, Teufel A, et al. Safety and efficacy of sorafenib in patients with advanced hepatocellular carcinoma in consideration of concomitant stage of liver cirrhosis. J Clin Gastroenterol 2009; 43: 489-95. (Among 34 patients with advanced HCC and cirrhosis treated with sorafenib, 53% developed liver dysfunction [bilirubin elevations, asterixis, liver failure] usually within a few weeks of starting, which was more frequent and severe in those with more advanced stages of cirrhosis [Child classes B and C]). 19247201
Stadler WM, Figlin RA, McDermott DF, Dutcher JP, Knox JJ, Miller WH Jr, Hainsworth JD, et al.; ARCCS Study Investigators. Safety and efficacy results of the advanced renal cell carcinoma sorafenib expanded access program in North America. Cancer 2010; 116: 1272-80. (Among 2504 patients with advanced renal cell cancer treated with sorafenib in an open access program, common side effects were hand-foot syndrome [18%], rash, hypertension and fatigue; ALT elevations and hepatotoxicity were not mentioned). 20082451
Herden U, Fischer L, Schäfer H, Nashan B, von Baehr V, Sterneck M. Sorafenib-induced severe acute hepatitis in a stable liver transplant recipient. Transplantation 2010; 90: 98-9. (58 year old man with HCC after liver transplant developed nausea and fever 5 days after starting sorafenib [bilirubin 12.0, ALT 893 U/L, GGT 726 U/L], with resolution within 8 weeks of stopping). 20606568
Hutson TE, Bellmunt J, Porta C, Szczylik C, Staehler M, Nadel A, Anderson S, et al.; Sorafenib TARGET Clinical Trial Group. Long-term safety of sorafenib in advanced renal cell carcinoma: follow-up of patients from phase III TARGET. Eur J Cancer 2010; 46: 2432-40. (Analysis of patients with advanced renal cancer who were treated with sorafenib for more than one year found adverse events were most frequent during the first 3 months of treatment [particularly rash and hand-foot syndrome]; ALT elevations and hepatotoxicity were not mentioned). 20656473
Rini BI, Escudier B, Tomczak P, Kaprin A, Szczylik C, Hutson TE, Michaelson MD, et al. Comparative effectiveness of axitinib versus sorafenib in advanced renal cell carcinoma (AXIS): a randomised phase 3 trial. Lancet 2011; 378 (9807): 1931-9. (Among 723 patients with advanced renal cell carcinoma, progression free survival was longer with axitinib [6.7 months] than sorafenib [4.7 months] and side effects were common, although rates of hepatotoxicity or ALT elevations were not provided). 22056247
Beck J, Procopio G, Bajetta E, Keilholz U, Negrier S, Szczylik C, Bokemeyer C, et al. Final results of the European Advanced Renal Cell Carcinoma Sorafenib (EU-ARCCS) expanded-access study: a large open-label study in diverse community settings. Ann Oncol 2011; 22: 1812-23. (Among 1159 patients with advanced renal cell cancer treated with sorafenib in an open access program, adverse events occurred in 94% of patients, most frequently hand-foot syndrome [56%], rash [33%], alopecia [33%], fatigue [34%], diarrhea [55%] and hypertension [20%]; rates of ALT elevations and hepatotoxicity were not mentioned). 21324953
Fairfax BP, Pratap S, Roberts IS, Collier J, Kaplan R, Meade AM, Ritchie AW, et al. Fatal case of sorafenib-associated idiosyncratic hepatotoxicity in the adjuvant treatment of a patient with renal cell carcinoma. BMC Cancer 2012; 12: 590. (62 year old man with renal cell cancer developed fatigue at 4 and jaundice by 7 weeks after starting sorafenib [bilirubin 16.8 mg/dL, ALT 6935 U/L, Alk P 577 U/L], with progressive liver failure and death). 23231599
Raoul JL, Bruix J, Greten TF, Sherman M, Mazzaferro V, Hilgard P, Scherubl H, et al. Relationship between baseline hepatic status and outcome, and effect of sorafenib on liver function: SHARP trial subanalyses. J Hepatol 2012; 56: 1080-8. (Among 602 patients with HCC treated with sorafenib or placebo, survival was shorter among those with raised baseline levels liver tests, but levels were not altered by sorafenib therapy compared to placebo, although total and direct serum bilirubin levels with increased during the second month of sorafenib therapy). 22245896
Motzer RJ, Escudier B, Tomczak P, Hutson TE, Michaelson MD, Negrier S, Oudard S, et al. Axitinib versus sorafenib as second-line treatment for advanced renal cell carcinoma: overall survival analysis and updated results from a randomised phase 3 trial. Lancet Oncol 2013; 14: 552-62. (Among 723 patients with metastatic renal cell cancer treated with either axitinib or sorafenib, median overall survivals were similar with both agents [20.1 vs 19.2 months] and side effects common; no mention of ALT elevations or hepatotoxicity). 23598172
Herzog TJ, Scambia G, Kim BG, Lhommé C, Markowska J, Ray-Coquard I, Sehouli J, et al. A randomized phase II trial of maintenance therapy with Sorafenib in front-line ovarian carcinoma. Gynecol Oncol 2013; 130: 25-30. (Among 246 women with ovarian carcinoma treated with sorafenib or placebo, progression free survival was similar in both groups, whereas side effects were more common with sorafenib [67% vs 15%]; ALT elevations and hepatotoxicity were not mentioned). 23591401
Hutson TE, Lesovoy V, Al-Shukri S, Stus VP, Lipatov ON, Bair AH, Rosbrook B, et al. Axitinib versus sorafenib as first-line therapy in patients with metastatic renal-cell carcinoma: a randomised open-label phase 3 trial. Lancet Oncol 2013; 14: 1287-94. (Among 288 patients with metastatic renal cell carcinoma treated with either axitinib or sorafenib, progression free survival was similar in the two groups; side effects of diarrhea, hypertension, anorexia, weight loss and hoarseness were more common with axitinib; rates of ALT elevations and hepatotoxicity were not reported). 24206640
Shah RR, Morganroth J, Shah DR. Hepatotoxicity of tyrosine kinase inhibitors: clinical and regulatory perspectives. Drug Saf 2013; 36: 491-503. (Review of the hepatotoxicity of 18 tyrosine kinase inhibitors approved for use in cancer in the US as of 2013; sorafenib has been reported to cause ALT elevations in 21-24% of patients [≥5 times ULN in 2%] and has been linked to clinically apparent liver injury is several isolated case reports). 23620168
Brose MS, Nutting CM, Jarzab B, Elisei R, Siena S, Bastholt L, de la Fouchardiere C, et al.; on behalf of the DECISION investigators. Sorafenib in radioactive iodine-refractory, locally advanced or metastatic differentiated thyroid cancer: a randomised, double-blind, phase 3 trial. Lancet 2014; 384: 319-28. (Among 417 patients with advanced thyroid cancer, median progression free survival was 10.8 months in sorafenib- vs 5.8 months in placebo-treated patients, but side effects occurred in 99%, including hand-foot syndrome [76%], diarrhea [69%], rash [50%]; rates of ALT elevations and hepatotoxicity were not provided). 24768112
Sorafenib (Nexavar) for thyroid cancer. Med Lett Drugs Ther 2014; 56 (1443): 43-4. (Concise review of the efficacy, safety and costs of sorafenib in advanced thyroid cancer shortly after its approval for this use in the US, mentions that sorafenib can cause severe liver injury). 24869715
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 [6%] were attributed to antineoplastic agents including 9 to kinase inhibitors including imatinib [n=5], lapatinib [n=2] and regorafinib [n=1], but none were attributed to sorafenib). 25754159
Paz-Ares L, Hirsh V, Zhang L, de Marinis F, Yang JC, Wakelee HA, Seto T, et al. Monotherapy administration of sorafenib in patients with non-small cell lung cancer (MISSION) trial: a phase III, multicenter, placebo-controlled trial of sorafenib in patients with relapsed or refractory predominantly nonsquamous non-small-cell lung cancer after 2 or 3 previous treatment regimens. J Thorac Oncol 2015; 10: 1745-53. (Among 703 patients with advanced refractory or relapsed NSCLC who were treated with sorafenib vs placebo, median overall survival was similar in the two groups [8.2 vs 8.3 months] and side effects were more common with sorafenib [88% vs 49%], including rash [41% vs 4%] fatigue [36% vs 8%], diarrhea [36% vs 3%]; ALT elevations and liver related adverse events not mentioned). 26743856
Bruix J, Takayama T, Mazzaferro V, Chau GY, Yang J, Kudo M, Cai J, et al.; STORM investigators. Adjuvant sorafenib for hepatocellular carcinoma after resection or ablation (STORM): a phase 3, randomised, double-blind, placebo-controlled trial. Lancet Oncol 2015; 16: 1344-54. (Among 1114 patients with HCC, after successful resection or ablation, who were treated with sorafenib vs placebo for up to 4 years, recurrence free survival was simliar in the 2 groups [33 vs 34 months], while side effects were greater with sorafenib including hand-foot skin reaction [28% vs <1%], and ALT elevations [9% vs 7%] which were above 5 times ULN in 5% vs 2% and were associated with fatalities in 3 vs no patients [<1% vs 0%]). 26361969
Shantakumar S, Nordstrom BL, Djousse L, Hall SA, Gagnon DR, Fraeman KH, van Herk-Sukel M, et al. Occurrence of hepatotoxicity with pazopanib and other anti-VEGF treatments for renal cell carcinoma: an observational study utilizing a distributed database network. Cancer Chemother Pharmacol 2016; 78: 559-66. (Review of hepatotoxicity associated with anti-VEGF treatments of renal cell cancer from two large US health care databases, highest rates of ALT elevations were found with first line treatment with pazopanib [n=180] and slightly lower rates for sorafenib [n=160], sunitinib [n=721] and bevacizumab [n=83], but clinically apparent injury with jaundice was rare [1 case with sorafenib, 2 with sunitinib]). 27438066
Meyer T, Fox R, Ma YT, Ross PJ, James MW, Sturgess R, Stubbs C, et al. Sorafenib in combination with transarterial chemoembolisation in patients with unresectable hepatocellular carcinoma (TACE 2): a randomised placebo-controlled, double-blind, phase 3 trial. Lancet Gastroenterol Hepatol 2017; 2: 565-75. (Among 313 patients with unresectable HCC who were treated with sorafenib or placebo combined with transarterial chemoembolization, median progression free survival was similar in the 2 groups [238 vs 235 days] while adverse event rates were greater with sorafenib, including 3 treatment related deaths, two due to liver failure). 28648803
Bunchorntavakul C, Reddy KR. Drug hepatotoxicity: newer agents. Clin Liver Dis 2017; 21: 115-34. (Overview of hepatotoxicity of newer agents including tyrosine kinase inhibitors such as imatinib, bosutinib, nilotinib, ponatinib and sorafenib, all of which have been implicated in causing ALT and AST elevations [in 23-50% of patients] as well as clinically apparent liver injury). 27842767
Kudo M, Ueshima K, Yokosuka O, Ogasawara S, Obi S, Izumi N, Aikata H, et al.; SILIUS study group. Sorafenib plus low-dose cisplatin and fluorouracil hepatic arterial infusion chemotherapy versus sorafenib alone in patients with advanced hepatocellular carcinoma (SILIUS): a randomised, open label, phase 3 trial. Lancet Gastroenterol Hepatol 2018; 3: 424-32. (Among 206 patients with advanced HCC treated with sorafenib alone vs sorafenib with hepatic arterial infusions with cisplatin and fluorouracil, mean overall survival was similar in the two groups [11.8 vs 11.5 months] and adverse event rates were similar, ALT elevations arising in 67% vs 68% and to above 5 times ULN in 30% vs 29%). 29631810
Kudo M, Finn RS, Qin S, Han KH, Ikeda K, Piscaglia F, Baron A, et al. Lenvatinib versus sorafenib in first-line treatment of patients with unresectable hepatocellular carcinoma: a randomised phase 3 non-inferiority trial. Lancet 2018; 391: 1163-73. (Among 954 patients with unresectable HCC treated with sorafenib vs lenvatinib, median survival times were similar [12.3 vs 13.6 months] while adverse event profiles were different, but serious treatment related events were less with sorafenib [10% vs 18%] as were treatment related fatalities [4, 1% vs 11, 2%], of which 3 lenvatinib but no sorafenib related deaths were due to hepatic failure). 29433850

## OTHER REFERENCE LINKS

1. Recent References on Sorafenib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Sorafenib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Sorafenib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Sorafenib)